# Serotonin 5-HT3 Receptor Antagonists

## OVERVIEW

### Introduction

The serotonin type 3 (5-HT3) receptor antagonists are potent antiemetics used for prevention of postsurgical or chemotherapy induced nausea and vomiting and for some agents as therapy of diarrhea-predominant irritable bowel syndrome. The 5-HT3 receptor antagonists are associated with a low rate of transient serum enzyme elevations during therapy, but have been only rarely implicated in cases of clinically apparent liver injury.

### Background

The 5-HT3 receptor antagonists act to block the effects of serotonin on specific receptors that are found most frequently in the gastrointestinal tract and the central nervous system. The antiemetic effects appear to be the result of both central and peripheral inhibition of serotonin activity, with a decrease in vagal activity as well as interruption of pathways in the chemoreceptor trigger zone and solitary tract nucleus of the brainstem. 5-HT3 receptor antagonists in clinical use for treatment of nausea and vomiting in the United States include (with brand name and year of approval) granisetron (Kytril: 1994), dolasetron (Anzemet: 1997), ondansetron (Zofran: 1999), and palonosetron (Aloxi: 2003). All except palonosetron are also available in generic forms. These four 5-HT3 receptor antagonists are approved for prevention of nausea and vomiting after major surgery, chemotherapy or radiation therapy. They are sometimes used off-label to treat severe nausea and vomiting including that from hyperemesis gravidarum and acute gastroenteritis. They are not effective for motion sickness. These agents are generally given intravenously before or at the time of chemotherapy or surgery, but are also available as oral tablets, capsules and solutions, but are usually given for 1 to 3 days only. Common side effects include headache, fatigue, dizziness and constipation.

Alosetron (al oh’ se tron) is a 5-HT3 receptor blocker, but was developed and used largely for management of diarrhea-predominant irritable bowel syndrome rather than as an antiemetic. Its introduction in the 1990s however, was followed by cases of severe, even life-threatening, constipation which led to its withdrawal in 2000. Alosetron was reintroduced in 2002 with restrictions on its availability and limitation to women with severe diarrhea-predominant irritable bowel syndrome. Alosetron is available as 0.5 and 1.0 mg tablets generically and under the brand name Lotronex. The typical initial dose in adults is 0.5 mg twice daily, which can be increased to 1 mg twice daily if it is well tolerated. Side effects include abdominal pain and constipation, which can be severe resulting in intestinal obstruction, ileus, impaction and ischemic colitis. Patients treated with alosetron must be enrolled in a prescribing program and have regular monitoring for side effects.

Dolasetron (doe las’ e tron) is a 5-HT3 receptor blocker used as an antiemetic to prevent nausea and vomiting postoperatively or after cancer chemotherapy. It was first approved in 1997 and is available as tablets of 50 and 100 mg and as a solution for injection in single or multidose vials (20 mg/mL) under the brand name Anzemet. As with most 5-HT3 receptor blockers, the dose varies by mode of administration, indication and expected severity and duration of nausea. Side effects include headache, fatigue, diarrhea and dizziness. Dolasetron can prolong the QTc interval and is susceptible to drug-drug interactions.

Granisetron (gra nis’ e tron) is a 5-HT3 receptor blocker used as an antiemetic to prevent nausea and vomiting postoperatively or after cancer chemotherapy. Introduced in 1993, granisetron is available as tablets of 1 mg and as a solution for injection in single or multidose vials (1 mg/mL) generically and under the brand name Kytril. A transdermal patch of granisetron for prevention of chemotherapy associated nausea and vomiting is also available (Sancuso). As with other 5-HT3 receptor blockers, the dose varies by mode of administration, indication and expected severity and duration of nausea. Side effects of granisetron can include headache, fatigue, diarrhea and dizziness.

Ondansetron (on dan’ se tron) is a 5-HT3 receptor blocker that was developed as an antiemetic and was introduced in 1993, the first of this class of anti-emetic agents. The current indications are for prevention of nausea and vomiting postoperatively or after cancer chemotherapy. Ondansetron is available as tablets of 4, 8, 16 and 24 mg and as a solution for injection in single or multidose vials (2 mg/mL) in multiple generic forms and under the brand name Zofran. As with other 5-HT3 receptor blockers, the dose varies by mode of administration, indication and expected severity and duration of nausea. Side effects include headache, fatigue, diarrhea and dizziness. Ondansetron can prolong the QTc interval.

Palonosetron (pal” oh noe’ se tron) is a 5-HT3 receptor blocker that was developed as an antiemetic and introduced in 2003. The current indications are prevention of nausea and vomiting postoperatively or after cancer chemotherapy. Palonosetron is available as capsules of 0.5 mg and as a solution for injection in single or multidose vials (0.05 mg/mL) generically and under the brand name Aloxi. As with other 5-HT3 receptor blockers, the dose varies by mode of administration, indication and expected severity and duration of nausea. Side effects include headache, fatigue, diarrhea and dizziness. Palonosetron has not been shown to prolong the QTc interval.

### Hepatotoxicity

The 5-HT3 receptor antagonists have been linked to occasional instances of serum enzyme elevations during therapy, but these are generally mild and asymptomatic, resolving rapidly. Because they are used at the time of surgery and with chemotherapy, instances of liver injury arising after their use have been reported, but other drugs or factors may have played a role in the published cases. The rate of serum enzyme elevations with 5-HT3 receptor antagonist therapy has ranged from 1% to 8% and has generally been no greater than that observed with placebo therapy. While moderate serum enzyme elevations during 5-HT3 receptor antagonist therapy have been described, there have been have been only rare and isolated reports of clinically apparent acute liver injury with jaundice attributed to these agents. The onset of injury has been within 1 to 2 weeks of exposure and the pattern of injury hepatocellular and without immunoallergic or autoimmune features. Instances of recurrence after re-exposure have been published. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to the 5-HT3 receptor antagonists.

Alosetron likelihood score: D (possible cause of clinically apparent liver injury).

Dolasetron likelihood score: E (unlikely cause of clinically apparent liver injury).

Granisetron likelihood score: E (unlikely cause of clinically apparent liver injury).

Ondansetron likelihood score: D (possible cause of clinically apparent liver injury).

Palonosetron likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The 5-HT3 receptor blockers are metabolized in the liver, largely via the cytochrome P450 system, but appear to have a low potential for causing liver injury. All except alosetron are used in low doses for short periods of time which may account for their relative lack of hepatotoxicity.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clinically apparent liver injury due to the 5-HT3 receptor blockers is rare, generally mild and self-limited and frequently arises only after the agent is discontinued. Rechallenge with the same agent can lead to reoccurrence but in some instances patients have tolerated other 5-HT3 receptor blockers without reappearance of liver injury.

Drug Class: Gastrointestinal Agents, Antiemetics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alosetron – Generic, Lotronex®

Dolasetron – Generic, Anzemet®

Granisetron – Generic, Kytril®

Ondansetron – Generic, Zofran®

Palonosetron – Aloxi®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=serotonin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alosetron | 122852-42-0 | C17-H18-N4-O | Alosetron Chemical Structure
Dolasetron | 115956-12-2 | C19-H20-N2-O3 | Dolasetron Chemical Structure
Granisetron | 109889-09-0 | C18-H24-N4-O | Granisetron Chemical Structure
Ondansetron | 99614-02-5 | C18-H19-N3-O | Ondansetron Chemical Structure
Palonosetron | 135729-61-2 | C19-H24-N2-O | Palonosetron Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2018

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 717-8. (Expert review of hepatotoxicity published in 1999, does not discuss the serotonin type 3 receptor antagonists).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Smith RN. Safety of ondansetron. Eur J Cancer Clin Oncol 1989; 25 Suppl 1: S47-50; discussion S51-4. (Review of safety of ondansetron mentions that liver test abnormalities have been observed on therapy, but were likely due to underlying cancer, metastases or chemotherapy). 2533899
Hainsworth J, Harvey W, Pendergrass K, Kasimis B, Oblon D, Monaghan G, Gandara D, et al. A single-blind comparison of intravenous ondansetron, a selective serotonin antagonist, with intravenous metoclopramide in the prevention of nausea and vomiting associated with high-dose cisplatin chemotherapy. J Clin Oncol 1991; 9: 721-8. (Among 307 patients receiving cisplatin chemotherapy, ALT elevations above twice ULN occurred in 6% of those receiving ondansetron vs 0% on metoclopramide for prevention of nausea and vomiting, but all abnormalities were asymptomatic and resolved within 2 weeks). 1826739
Finn AL. Toxicity and side effects of ondansetron. Semin Oncol 1992; 19 (4 Suppl 10): 53-60. (Analysis of the preclinical and early clinical evaluation of ondansetron mentions that ALT elevations [at least twice ULN] occurred in 2% to 8% of patients receiving ondansetron during cisplatin chemotherapy, but only 1% receiving the agent for postoperative nausea and vomiting, a rate similar to that with placebo). 1387251
Sledge GW Jr, Einhorn L, Nagy C, House K. Phase III double-blind comparison of intravenous ondansetron and metoclopramide as antiemetic therapy for patients receiving multiple-day cisplatin-based chemotherapy. Cancer 1992; 70: 2524-8. (Among 45 patients with cancer receiving cisplatin based chemotherapy, 1 of 22 patients who were treated with metoclopramide versus 3 of 23 on ondansetron developed serum ALT elevations, but none developed signs of symptoms of liver injury). 1423181
Chen M, Tanner A, Gallo-Torres H. Anaphylactoid-anaphylactic reactions associated with ondansetron. Ann Intern Med 1993; 119: 862. (Letter from the FDA summarizing 24 reports of anaphylactic reactions to ondansetron, occurring after 1-3 courses and marked by urticaria, angioedema, hypotension, bronchospasm and dyspnea, at least one case of which was fatal). 8379613
Cersosimo RJ. Hepatotoxicity associated with cisplatin chemotherapy. Ann Pharmacother 1993; 27: 438-41. (69 year old man developed serum aminotransferase elevations after each of three courses of chemotherapy with cisplatin, peak ALT being lower with each course [203, 77 and 56 U/L], peaking on day 2 to 3 and falling to normal by day 10, with ondansetron given during the second and third course). 8477119
Verrill M, Judson I. Jaundice with ondansetron. Lancet 1994; 344 (8916): 190-1. (35 year old man developed jaundice 10 days after two 8 mg intravenous doses of ondansetron [bilirubin 8.8 mg/dL, ALT 153 U/L, Alk P 77 U/L], resolving within 8 days; jaundice with fever recurring 9 days after reexposure [bilirubin 9.0 mg/dL], but not recurring when given granisetron). 7912780
Wilde MI, Markham A. Ondansetron. A review of its pharmacology and preliminary clinical findings in novel applications. Drugs 1996; 52:773-94. (Review of the structure, mechanism of action, pharmacokinetics, efficacy and safety of ondansetron as an antiemetic agent mentions that abnormalities of liver tests have been associated with ondansetron therapy and severe symptomatic jaundice has been reported in one case). 9118822
Chevallier B, Cappelaere P, Splinter T, Fabbro M, Wendling JL, Cals L, Catimel G, et al. A double-blind, multicentre comparison of intravenous dolasetron mesilate and metoclopramide in the prevention of nausea and vomiting in cancer patients receiving high-dose cisplatin chemotherapy. Support Care Cancer 1997; 5: 22-30. (Among 226 patients with cancer receiving cisplatin, 4% of 157 receiving dolasetron vs 1% receiving metoclopramide had liver test abnormalities during treatment). 9010986
Balfour JA, Goa KL. Dolasetron. A review of its pharmacology and therapeutic potential in the management of nausea and vomiting induced by chemotherapy, radiotherapy or surgery. Drugs 1997; 54: 273-98. (Review of the pharmacokinetics, efficacy and safety of dolasetron as therapy of nausea and vomiting caused by chemotherapy or surgery; liver test abnormalities have been reported, but not characterized). 9257083
Weiss KS. Anaphylactic reaction to ondansetron. Arch Intern Med 2001; 161: 2263. (61 year old woman developed flushing and tongue swelling 5 minutes after an initial infusion of ondansetron, resolving with symptomatic therapy; no mention of ALT levels). 11575988
Camilleri M, Chey WY, Mayer EA, Northcutt AR, Heath A, Dukes GE, McSorley D, et al. A randomized controlled clinical trial of the serotonin type 3 receptor antagonist alosetron in women with diarrhea-predominant irritable bowel syndrome. Arch Intern Med 2001; 161: 1733-40. (Among 626 patients with diarrhea predominant IBS treated with either alosetron [1 mg] or placebo twice daily for 12 weeks, constipation was the most common adverse event [25% vs 5%] and "laboratory values were not significantly affected by alosetron treatment"). 11485506
Kamm MA. Review article: the complexity of drug development for irritable bowel syndrome. Aliment Pharmacol Ther 2002; 16: 343-51. (History of development of serotonin modifying drugs for irritable bowel syndrome [IBS], and particularly alosetron which is 10 times more potent than ondansetron and was approved for use in diarrhea predominant IBS, but was later withdrawn because of frequent complications of constipation and several episodes of ischemic colitis, some of which were fatal). 11876686
Cremonini F, Delgado-Aros S, Camilleri M. Efficacy of alosetron in irritable bowel syndrome: a meta-analysis of randomized controlled trials. Neurogastroenterol Motil 2003; 15: 79-86. (Analysis of 6 controlled trials of alosetron vs placebo in IBS found no significant differences in frequency of adverse events, except for constipation, between the two groups). 12588472
Kim JS, Baek JY, Park SR, Choi IS, Kim SI, Kim DW, Im SA, et al. Open-label, randomized comparison of the efficacy of intravenous dolasetron mesylate and ondansetron in the prevention of acute and delayed cisplatin-induced emesis in cancer patients. Cancer Res Treat 2004 36: 372-6. (Among 112 patients given ondansetron or dolasetron to prevent chemotherapy induced nausea and vomiting, there were no "clinically relevant differences found between the treatment groups with respect to laboratory test results"). 20368831
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to antiemetic agents or the 5-HT3 receptor blockers). 15390328
Turgeon DK, Tayeh N, Fontana RJ. Acute hepatitis associated with alosetron(Lotronex). J Clin Gastroenterol 2005; 39: 641-2. (39 year old woman developed malaise and nausea four weeks after starting alosetron for chronic diarrhea [peak bilirubin normal, ALT 160 U/L, Alk 342 U/L], which had returned to normal when tested 6 months later). 16000936
Piche T, Vanbiervliet G, Cherikh F, Antoun Z, Huet PM, Gelsi E, Demarquay JF, et al. Effect of ondansetron, a 5-HT3 receptor antagonist, on fatigue in chronic hepatitis C: a randomised, double blind, placebo controlled study. Gut 2005; 54: 1169-73. (Among 36 patients with chronic hepatitis C and fatigue treated with tablets of ondansetron [4 mg] or placebo tablets twice daily for one month, there were no significant changes in ALT levels in either group). 16009690
Theal JJ, Toosi MN, Girlan L, Heslegrave RJ, Huet PM, Burak KW, Swain M, et al. A randomized, controlled crossover trial of ondansetron in patients with primary biliary cirrhosis and fatigue. Hepatology 2005; 41: 1305-12. (Among 60 patients with primary biliary cirrhosis and fatigue treated with ondansetron [4 mg three times daily] or placebo for 4 days, there was no evidence of a reduction in fatigue; serum ALT levels did not change). 15915460
O'Donohue JW, Pereira SP, Ashdown AC, Haigh CG, Wilkinson JR, Williams R. A controlled trial of ondansetron in the pruritus of cholestasis. Aliment Pharmacol Ther 2005; 21: 1041-5. (Among 19 patients with resistant pruritus treated with ondansetron [8 mg twice daily] or placebo for 5 days, scratching and pruritus decreased with the medication and one patient developed a rise in Alk P [306 to 812 U/L] and bilirubin [3.7 to 44.3 mg/dL], but no further details given). 15813840
Lewandowski MJ, Chapman SA. Ondansetron-induced aminotransferase level elevation: case report and review of the literature. Pharmacotherapy 2008; 28: 1542-6. (44 year old woman received intravenous ondansetron on 3 occasions during emergency room evaluation for chest pain and nausea and developed ALT elevations within 12-48 hours each time [bilirubin 0.7 mg/dL, ALT 816, 798 and 761 U/L, Alk P 121 U/L], which fell to normal within a few days). 19025436
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to anti emetic agents or the 5-HT3 receptor blockers). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiemetic agents or the 5-HT3 receptor blockers). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic, but no 5-HT3 receptor blocker was listed among the 41 most commonly implicated agents). 21039766
Vergne-Salle P, Dufauret-Lombard C, Bonnet C, Simon A, Trèves R, Bonnabau H, Bertin P. A randomised, double-blind, placebo-controlled trial of dolasetron, a 5-hydroxytryptamine 3 receptor antagonist, in patients with fibromyalgia. Eur J Pain 2011; 15: 509-14. (Among 60 patients with fibromyalgia treated with 4 monthly infusions of dolasetron or placebo, there were "no meaningful changes" in ALT, AST or Alk P levels; one patient on dolasetron developed rise in ALT to 4 times ULN that resolved within 3 weeks). 21036635
Schwartzberg L, Barbour SY, Morrow GR, Ballinari G, Thorn MD, Cox D. Pooled analysis of phase III clinical studies of palonosetron versus ondansetron, dolasetron, and granisetron in the prevention of chemotherapy-induced nausea and vomiting(CINV). Support Care Cancer 2014; 22: 469-77. (Analysis of 4 controlled trials comparing palonosetron to ondansetron, dolasetron and granisetron for prevention of nausea and vomiting after cancer chemotherapy found similar rates of adverse events 20-27%; ALT elevations in 0.2% and 2.1% of patients on palonosetron and 3.1% on other 5-HT3 receptor antagonists). 24141698
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antiemetics or 5-HT3 receptor blockers). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; antiemetics and metoclopramide were not listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a serotonin 5-HT3 receptor antagonist). 25754159
Simino GP, Marra LP, Andrade EI, Acúrcio Fde A, Reis IA, De Araújo VE, Cherchiglia ML. Efficacy, safety and effectiveness of ondansetron compared to other serotonin-3 receptor antagonists (5-HT3RAs) used to control chemotherapy-induced nausea and vomiting: systematic review and meta-analysis. Expert Rev Clin Pharmacol 2016; 9: 1183-94. (Review of the literature on the safety and efficacy of the 5-HT3 receptor blockers used as antiemetics, discusses symptoms of headache, dizziness, constipation and diarrhea, but not ALT or other laboratory abnormalities; no mention of hepatotoxicity). 27180992
Park H, Oh K, Lee H, Lee JH, Kang SM, Park SY, Kwon HS, Cho YS, Moon HB, Kim TB. Palonosetron-induced anaphylaxis during general anesthesia: A case report. Allergy Asthma Immunol Res 2017; 9: 92-5. (37 year old man developed hypotension immediately after an infusion of palonosetron during surgery with subsequent rash and facial edema, responding to corticosteroid therapy; no mention of ALT elevations or hepatotoxicity). 27826967
Kovács G, Wachtel A, Basharova E, Spinelli T, Nicolas P, Kabickova E. Palonosetron compared with ondansetron in pediatric cancer patients: multicycle analysis of a randomized Phase III study. Future Oncol 2017; 13: 1685-98. (Among 502 children receiving up to 4 cycles of cancer chemotherapy who were treated with one of two doses of palonosetron or ondansetron, higher doses of palonosetron were associated with fewer emetic episodes while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 28569078
Takahashi T, Okada T, Ikejiri F, Ito S, Okada Y, Takahashi F, Kumanomido S, et al. A prospective study of palonosetron for prevention of chemotherapy-induced nausea and vomiting in malignant lymphoma patients following highly emetogenic chemotherapy. Int J Clin Oncol 2017 Aug 19. (Among 59 patients with lymphoma treated with palonosetron, 94% had no nausea or vomiting and adverse events were mild including ALT elevations in 6 [12%], all of which were less than 5 times ULN). 28823027